# Antidepressant Agents

## OVERVIEW

The antidepressants are some of the most commonly prescribed medications in current use. They are also important causes of drug induced liver injury accounting for 2% to 5% of clinically apparent cases. The antidepressants can be grouped into four categories: monamine oxidase inhibitors, tricyclic antidepressants, selective serotonin reuptake inhibitors, and miscellaneous agents.

The monamine oxidase inhibitors are a large group of hydrazide derivatives which were found to have antidepressant activity when first used in the therapy of tuberculosis in the 1950s. These agents inhibit the enzyme monamine oxidase that is responsible for inactivation of many amine neurotransmitters such as norepinephrine and serotonin, thus increasing their levels and activity in the brain. MAO inhibitors (with initial trade name and year of approval) currently in clinical use for depression include phenelzine (Nardil: 1961), tranylcypromine (Parnate: 1961), and isocarboxazid (Marplan: 1959). MAO inhibitors are currently not widely used, having been replaced by the tricyclic antidepressants and selective serotonin reuptake inhibitors which have greater potency and fewer adverse side effects. The MAO inhibitors can cause serum aminotransferase elevations and rarely lead to clinically apparent liver injury, generally with a hepatitis-like clinical presentation 1 to 3 months after starting therapy.

The tricyclic antidepressants share a tricyclic chemical structure somewhat resembling the phenothiazines. The tricyclics are believed to act by inhibition of reuptake of serotonin and norephinephrine, thus increasing levels of these neurotransmitters. Tricyclic antidepressants in current use include amitriptyline (Elavil: 1961), clomipramine (Anafranil: 1989), desipramine (Norpramin: 1964), doxepin (Sinequan: 1969), imipramine (Tofranil: 1959), nortriptyline (Aventyl or Pamelor: 1964) and protriptyline (Vivactil: 1967). Two more recently approved agents are usually categorized as tricyclics, but have some unique characteristics: trimipramine (Surmontil: 1979) and amoxapine (Asendin: 1992). The various tricyclic antidepressants are capable of causing transient serum aminotransferase elevations to varying degrees and, in rare instances, clinically apparent acute liver injury. Various pattern of hepatic injury have been associated with different tricyclic antidepressants.

The selective serotonin reuptake inhibitors (SSRIs) are a group of structurally unrelated agents characterized by a common mechanism of action, the inhibition of reuptake of serotonin in synaptic clefts which results in an increase in brain serotonin activity. These agents are considered selective, because they have little activity in blocking reuptake of norepinephrine or other neurotransmitters. The SSRIs are currently the most commonly used antidepressants. Those in current use include citalopram (Celexa: 1998), escitalopram (Lexapro: 2002), fluoxetine (Prozac: 1987), fluvoxamine (Luvox: 1994), paroxetine (Paxil: 1992), sertraline (Zoloft: 1991), venlafaxine (Effexor: 1965) and duloxetine (Cymbalta: 2004). Two more recently approved serotonergic agents are unique in that they have bimodal activity, inhibiting serotonin reuptake like typical SSRIs, but also having partial agonist-antagonist activity directly against serotonin receptors: vilazodone (Viibryd: 2011) and vortioxetine (Brintellix: 2013). Serum aminotransferase elevations occur in up to 10% of patients taking conventional SSRIs. Varying patterns of acute liver injury have been described with most agents, but clinically apparent liver injury due to these agents is rare.

Miscellaneous antidepressants include tetracyclic agents that act by inhibition of reuptake of both serotonin and norepinephrine and are thus known as SNRIs (mirtazapine: Remeron, 1996), aminoketones (bupropion: Wellbutrin: 1985), and triazolopyradine derivatives (trazodone: Desyrel, 1981; and nefazodone: formerly Serzone, 1994). The latter two agents, but particularly nefazodone, have been linked to cases of drug induced acute liver injury that can be severe and lead to liver failure and death.

Several antidepressant medications have been withdrawn from use because of their potential for hepatotoxicity. Thus, the initial MAO inhibitor and hydralazine derivative iproniazid was introduced into clinical use in 1956, but withdrawn in 1961 because of multiple reports of acute hepatic injury more than 10% of which were fatal. Amineptine is a tricyclic antidepressant that was introduced in 1978 in Europe, but subsequently withdrawn because of several reports of prolonged cholestatic hepatic injury associated with its use in rates higher than with other tricyclic antidepressants. Finally, nefazodone, an antidepressant related in structure to trazodone that was approved for use in 1997, was withdrawn by the sponsor in 2003 after multiple reports of acute liver failure arising in patients treated for more than 4 to 6 months. Nefazodone, however, remains available in generic forms.

The following drug subclasses and drug records are discussed individually:

- MAO Inhibitors
  - Isocarboxazid, Phenelzine, Tranylcypromine
- SNRIs
  - Duloxetine, Levomilnacipran, Venlafaxine
- SSRIs
  - Citalopram, Escitalopram, Fluoxetine, Fluvoxamine, Paroxetine, Sertraline , Vilazodone, Vortioxetine
- Tricyclics
  - Amitriptyline, Amoxapine, Clomipramine, Desipramine, Doxepin, Imipramine, Nortriptyline, Protriptyline, Trimipramine
- Miscellaneous
  - Brexanolone, Bupropion, Esketamine, Flibanserin, Mirtazapine, Nefazodone, Trazodone